# Sulfonylureas, First Generation

## OVERVIEW

### Introduction

The first generation sulfonylureas include acetohexamide, chlorpropamide, tolazamide and tolbutamide, oral hypoglycemic agents that are used in therapy of type 2 diabetes. They are well known, but rare causes of clinically apparent liver injury.

### Background

The sulfonylureas are substituted arylsulfonylureas, their differences being in the types of substitutions at the two ends of the molecule. The sulfonylureas lower blood glucose through an increase in secretion of insulin from the pancreatic beta cells. They may also have other extra-pancreatic hypoglycemic actions that are important during prolonged therapy. The first generation sulfonylureas have been largely replaced in routine use by the second generation agents, which are more potent and administered in lower doses largely on a once daily basis. Nevertheless, some patients are still maintained on first generation agents. Chlorpropamide (klor proe' pa mide) is available in generic forms and previously under the brand name of Diabinese in tablets of 100 and 250 mg, the recommended dose initially being 100 to 250 mg daily with increases every 5 to 7 days to a maximum of 750 mg daily. Tolazamide (tol az' a mide) is available in generic forms and under the brand name of Tolinase in tablets of 100, 250 and 500 mg, the recommended dose initially being 100 to 250 mg once daily, with increases thereafter to a maximum of 1000 mg daily. Tolbutamide (tol bue' ta mide) is available in generic forms and previously under the brand name of Orinase in tablets of 500 mg, the recommended dose initially being 1000 to 2000 mg daily in two divided doses, with increases thereafter to a maximum of 3000 mg daily. Acetohexamide (a seet" oh hex' a mide) was previously available in generic forms and under the brand name of Dymelor in tablets of 250 and 500 mg, the recommended dose initially being 250 to 500 mg daily with increases thereafter to a maximum of 1500 mg daily. Acetahexamide has been withdrawn from use and is no longer available. Common side effects of the first generation sulfonylureas include headache, dizziness, paresthesias, abdominal discomfort, and nausea. These agents are also associated with an “antabuse” like response to alcohol (flushing, nausea, palpitations, hypotension and dizziness) and patients should be advised not to drink alcoholic beverages while on these agents. All sulfonylureas can cause hypoglycemia.

### Hepatotoxicity

Minor enzyme elevations have been reported to occur during sulfonylurea therapy in less than 1% of patients, rates that are similar to what occurs with placebo therapy. Clinically apparent liver injury from the sulfonylureas is rare, but has been reported for virtually all of the currently available forms and appears to represent a class effect, the pattern of injury being similar with the different agents. The liver injury usually appears within 2 to 12 weeks of starting the medication, usually with symptoms of fatigue, nausea and abdominal discomfort, followed by dark urine, itching and jaundice. Various combinations of hepatocellular and cholestatic injury have been described with sulfonylurea induced liver injury, and many cases are reported to be mixed. Allergic manifestations (fever, rash, eosinophilia) are found in up to half of cases, but autoantibody formation is not typical. Because this agent is usually given in combination with other hypoglycemic agents, many of which also cause liver injury, it can be difficult to establish whether the injury is due to the sulfonylurea or another agent. The timing of injury is perhaps most characteristic, although in some instances the hepatic injury has arisen many months to years after starting treatment, particularly after a recent increase in dosage. Recovery is usually rapid after the medication is stopped. Interestingly, the occurrence of hepatotoxicity with one sulfonylurea does not mean that similar liver injury will arise with another; many instances of a lack of recurrence with rechallenge (at lower doses) have been published. If toxicities arise, the second generation sulfonylureas should be preferred over the first generation agents. In recent summary recommendations on therapy of type 2 diabetes, the first generation sulfonylureas are usually not mentioned.

Likehood score: B (likely cause of liver injury as a class, most cases linked to chlorpropamide which was also the most commonly used in the past).

### Mechanism of Injury

The mechanism of liver injury due to sulfonylureas is unknown, but suspected to be due to hypersensitivity. Cross reactivity to reactions to sulfonamides can occur, but not invariably, and the overall pattern of injury and outcome of sulfonylurea associated hepatic injury does not resemble the acute, immunoallergic pattern that is common with the sulfonamides. Nevertheless, the sulfonylureas should be used with caution in patients with sulfonamide hypersensitivity or a history of sulfonamide hepatotoxicity. In either case, rechallenge can lead to recurrence and should be avoided.

### Outcome and Management

The liver injury from the sulfonylureas usually resolves rapidly once the agent is stopped, but chronic injury has been described in rare cases. Despite the usual cholestatic form of injury, cases of progressive hepatic failure and death have been described, particularly in the elderly or patients with multiple other medical problems and when the medication is not promptly withdrawn. There can be cross sensitivity between the different first generation sulfonylureas, and even switching to a second generation agent should be done with caution and appropriate monitoring. In cases in which multiple hypoglycemic agents are being used when the liver injury appears, rechallenge with the agent least likely associated with the injury is appropriate.

References to the first generation sulfonylureas and a representative case of hepatotoxicity due to their use are given in the Overview section on the Sulfonylureas (updated March 2018).

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass, Sulfonylureas: Second Generation Sulfonylureas

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acetohexamide – Dymelor®

Chlorpropamide – Diabinese®

Tolazamide – Tolinase®

Tolbutamide – Orinase®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Acetohexamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acetohexamide | 968-81-0 | C15-H20-N2-O4-S | Acetohexamide chemical structure
Chlorpropamide | 94-20-2 | C10-H13-Cl-N2-O3-S | Chlorpropamide chemical structure
Tolazamide | 1156-19-0 | C14-H21-N3-O3-S | Tolazamide chemical structure
Tolbutamide | 64-77-7 | C12-H18-N2-O3-S | Tolbutamide chemical structure